# Edaravone

## OVERVIEW

### Introduction

Edaravone is a free radical scavenger and neuroprotective agent used for therapy of amyotrophic lateral sclerosis. Edaravone is associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent, acute liver injury.

### Background

Edaravone (e dar' a vone) is a free radical scavenger that has been used as a neuroprotective agent in patients with ischemic stroke and amyotrophic lateral sclerosis. The mechanism by which it protects neurons from toxic injury is unknown, but it appears to eliminate lipid peroxide and hydroxyl radicals by electron transfer, thus decreasing oxidative cellular injury which is believed to play an important role in the progressive neurologic damage in amyotrophic lateral sclerosis. Studies in patients with amyotrophic lateral sclerosis suggest that edaravone may slow disease progression and neurologic deterioration. Edaravone was approved for this indication in the United States in 2017 and is increasingly used in management of amyotrophic lateral sclerosis. Edaravone is available in solution for intravenous infusion, generally in single-dose bags of 30 mg/100 mL. The recommended dose is 60 mg given intravenously over 60 minutes for the first 14 days of an initial 28-day cycle, followed by the first 10 days of subsequent cycles. Common side effects include local infusion reactions, confusion, gait disturbance and headache. More severe but uncommon side effects include hypersensitivity reactions including angioedema and anaphylaxis.

### Hepatotoxicity

Serum aminotransferase elevations occur in a small proportion of patients on edaravone therapy, but the frequency, timing of onset, duration and severity of these elevations has not been defined. The rates of abnormal liver tests during edaravone therapy were said to be similar to those during placebo treatment. Most elevations resolved spontaneously, and there were no reports of drug discontinuation for serum enzyme elevations. Clinically apparent liver injury due to edaravone was not reported in the prelicensure trials and has not been reported with subsequent clinical use of edaravone, but the numbers of patients treated have been few. Thus, clinically apparent liver injury from edaravone must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which edaravone might cause hepatotoxicity is unclear. Edaravone is extensively metabolized by the liver to sulfate and glucuronide conjugates that also demonstrate no toxicity in animal models. Edaravone has not been found to have significant drug-drug interactions.

### Outcome and Management

The liver injury arising during edaravone therapy has consisted of minor and transient elevations in serum aminotransferase levels in a small proportion of patients. Routine monitoring of serum aminotransferase levels is not recommended. However, if aminotransferase elevations greater than 5 times ULN are detected during therapy, edaravone should be temporarily discontinued and reinitiated only after resolution of the abnormalities and with close monitoring of liver tests thereafter. Edaravone has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome.

Drug Class: Alzheimer Disease Agents, Amyotrophic Lateral Sclerosis Agents

Other Related Drugs: Riluzole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Edaravone – Radicava®

DRUG CLASS

Amyotrophic Lateral Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Edaravone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Edaravone | 89-25-8 | C10-H10-N2-O | Edaravone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 09 April 2019

Abbreviations used: ALS, amyotrophic lateral sclerosis

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 709-42. (Expert review of hepatotoxicity published in 1999 before the availability of edaravone).
Larrey D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 518. (Review of hepatotoxicity of psychotropic agents published in 2007 before the availability of edaravone).
Roberson ED. Amyotrophic lateral sclerosis (ALT). Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 335-7. (Textbook of pharmacology and therapeutics).
Wokke J. Riluzole. Lancet 1996; 348 (9030): 795-9. (Review of structure, mechanisms of action, pharmacokinetics, efficacy and safety of riluzole; mentions that ALT and AST elevations occur not infrequently, but are usually less than 3 times ULN and that no case of jaundice has been reported). 8813989
Miller RG, Mitchell JD, Lyon M, Moore DH. Riluzole for amyotrophic lateral sclerosis (ALS)/motor neuron disease (MND). Amyotroph Lateral Scler Other Motor Neuron Disord 2003; 4: 191-206. (Systematic review of safety and efficacy of riluzole identified 4 controlled trials; ALT elevations >3 times ULN were 2.6 times more frequent in riluzole than placebo treated subjects). 13129806
Yoshino H, Kimura A. Investigation of the therapeutic effects of edaravone, a free radical scavenger, on amyotrophic lateral sclerosis (Phase II study). Amyotrophic Lateral Scler 2006: 7: 247-51. (Among 20 patients with ALS treated with 30 or 60 mg of edaravone intravenously once daily for 14 days in six 28-day cycles, the rate of worsening of symptom scores decreased in the higher dose group and adverse events were uncommon; “In several cases, laboratory tests showed abnormalities, but none was considered to be a consequence of edaravone administration”).
Shinohara Y, Saito I, Kobayashi S, Uchiyama S. Edaravone (radical scavenger) versus sodium ozagrel (antiplatelet agent) in acute noncardioembolic ischemic stroke (EDO trial). Cerebrovasc Dis 2009; 27: 485-92. (Among 401 patients with acute ischemic stroke treated with 14 days of intravenous edaravone vs ozagrel, symptom and function scales at 3 suggesting noninferiority while both total and serious adverse event rates were similar including renal, cerebrovascular and hepatic [22% vs 24%], but no details were provided). 19321945
Abe K, Itoyama Y, Sobue G, Tsuji S, Aoki M, Doyu M, Hamada C, et al.; Edaravone ALS Study Group. Confirmatory double-blind, parallel-group, placebo-controlled study of efficacy and safety of edaravone (MCI-186) in amyotrophic lateral sclerosis patients. Amyotroph Lateral Scler Frontotemporal Degener 2014; 15: 610-7. (Among 206 patients with ALS treated with 6 cycles of intravenous edaravone or placebo [24 weeks], there were no differences in changes in ALS functional rating scale, disease progression or deaths, and adverse event rates were similar although headache, bruising, gait disturbance and rash were more frequent with edaravone). 25286015
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to central nervous system agents, but none to edaravone, riluzole or other drugs used to treat ALS or Alzheimer disease). 25754159
Writing Group; Edaravone (MCI-186) ALS 19 Study Group. Safety and efficacy of edaravone in well- defined patients with amyotrophic lateral sclerosis: a randomised, double-blind, placebo-controlled trial. Lancet Neurol 2017; 16: 505-12. (Among 137 patients with early stage ALS treated with 6 cycles of intravenous edaravone or placebo [24 weeks], ALS functional rating scores decreased less in the edaravone treated subjects [-5.0 vs -7.5] and adverse event rates were similar including “abnormal liver function tests” which occurred in one patient in both groups). 28522181
Writing Group on Behalf of the Edaravone (MCI-186) ALS 19 Study Group. Exploratory double-blind, parallel-group, placebo-controlled extension study of edaravone (MCI-186) in amyotrophic lateral sclerosis. Amyotroph Lateral Scler Frontotemporal Degener 2017; 18 (sup1): 20-31. (Among 181 patients with ALS who completed a randomized controlled trial of edaravone [Abe 2014], 93 who had received edaravone were either continued on 6 cycles of active drug or switched to placebo, during which changes in the ALS functional rating scale were similar as were adverse event rates and there were no differences in laboratory measurements between the two groups). 28872918
Kalin A, Medina-Paraiso E, Ishizaki K, Kim A, Zhang Y, Saita T, Wasaki M. A safety analysis of edaravone (MCI-186) during the first six cycles (24 weeks) of amyotrophic lateral sclerosis (ALS) therapy from the double-blind period in three randomized, placebo-controlled studies. Amyotroph Lateral Scler Frontotemporal Degener 2017; 18 (sup1): 71-9. (Pooled analysis of 3 placebo-controlled trials in 368 patients found some treatment emergent adverse events that occurred more frequently with edaravone were bruising [15% vs 9%], gait disturbance [12.5% vs 9%], headache [8% vs 5%, eczema [6.5% vs 2%] and contact dermatitis [6% vs 3%], while “hepatic function abnormal” arose in 1.2% vs 2.7%). 28872919
Writing Group on Behalf of the Edaravone (MCI-186) ALS 19 Study Group. Open-label 24-week extension study of edaravone (MCI-186) in amyotrophic lateral sclerosis. Amyotroph Lateral Scler Frontotemporal Degener 2017; 18 (sup1): 55-63. (Among 123 patients with early stage ALS treated in a placebo-controlled trial [Writing Group 2017] who continued in an extension study of edaravone for another 6 cycles [24 weeks], the decline in functional rating scores was linear and no new safety concerns were detected and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 28872920
Oskarsson B, Gendron TF, Staff NP. Amyotrophic lateral sclerosis: an update for 2018. Mayo Clin Proc 2018; 93: 1617-28. (Review of the diagnosis, epidemiology, pathogenesis, clinical features, management and treatment of ALS including discussion of edaravone). 30401437

## OTHER REFERENCE LINKS

1. Recent References on Edaravone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Edaravone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Edaravone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Edaravone)